# Lamotrigine

## OVERVIEW

### Introduction

Lamotrigine is a widely used anticonvulsant used for several forms of epilepsy as well as for bipolar disorder and off label for other psychiatric and neurologic conditions such as severe depression, peripheral neuropathy, trigeminal neuralgia, and migraine. Lamotrigine is a rare but well-known cause of idiosyncratic liver injury, that can be severe and even fatal.

### Background

Lamotrigine (la moe' tri jeen) is a phenyltriazine and belongs to an anticonvulsant class of its own, unrelated to the common aromatic anticonvulsants such as phenytoin. Lamotrigine is believed to inhibit the release of excitatory neurotransmitters, particularly glutamate and aspartate but may also act directly on sodium channels on neuronal cells and to stabilize neuronal membranes. Lamotrigine was approved for use in the United States for epilepsy in 1994 and is still in common use. Lamotrigine is indicated for prevention and management of partial and generalized seizures either alone or in combination with other anticonvulsant agents. Lamotrigine is also approved for use as a mood stabilizer in bipolar disorders and is used off label for several other neurologic and psychiatric conditions, including severe depression, peripheral neuropathy, migraine headaches, and trigeminal neuralgia. Lamotrigine is available as tablets (including immediate and extended release) of 25, 100, 150, 200, 300, and 400 mg in multiple generic formulations and under the brand name Lamictal. Pediatric formulations are available as chewable tablets in doses of 2, 5 and 25 mg. Recommended doses vary by age, indication, tolerance, and concomitant medications. Lamotrigine should be started in low doses with gradual escalation. The typical recommended starting dose in adults is 25 mg taken orally once daily, escalating to a maximum dose of 400 mg daily. Common side effects include somnolence, fatigue, nervousness, dizziness, tremor, and rash. Uncommon but potentially severe adverse events include serious skin rashes such as DRESS syndrome, Stevens Johnson syndrome, and toxic epidermal necrolysis, hemophagocytic lymphohistiocytosis (HLH), hypersensitivity reactions, acute liver injury, cytopenias, blood dyscrasias, cardiac arrhythmias, aseptic meningitis, and suicidal behaviors and ideation.

### Hepatotoxicity

Prospective studies suggest that less than 1% of subjects develop elevations in serum aminotransferase levels during long term lamotrigine therapy. However, clinically apparent hepatotoxicity from lamotrigine is well known and is estimated to occur in one in 2,000 to 10,000 treated patients. The liver injury is usually part of a systemic immuno-allergic reaction (anticonvulsant hypersensitivity syndrome [AHS] or drug rash with eosinophilia and systemic symptoms [DRESS] syndrome). The latency is typically short, ranging from one to several weeks after starting therapy or after a major increase in dose. Presenting symptoms are a diffuse maculopapular rash, followed in a few days by high fever, nausea and vomiting. The rash can develop into a systemic hypersensitivity reaction and multiorgan failure or be associated with jaundice and hepatitis. Eosinophilia is common, and facial edema, lymphadenopathy, and atypical lymphocytosis can occur. Some cases resemble the severe cutaneous reactions of Stephens Johnson syndrome (SJS) or toxic epidermal necrolysis (TEN). The pattern of liver enzyme elevations is usually hepatocellular, and severity ranges from mild-to-moderate ALT elevations accompanying the generalized hypersensitivity reaction, to an icteric hepatitis, to a severe hepatitis and acute liver failure. Liver biopsy shows portal inflammation, hepatocellular necrosis and bile duct proliferation. In some instances of severe hypersensitivity syndrome with acute multiorgan failure, the hepatic involvement may represent ischemic injury.

Lamotrigine has also been linked to rare instances of hemophagocytic lymphohistiocytosis (HLH), a rare and severe immune related reaction characterized by unremitting activation of CD8+ T cells and macrophages that causes multiorgan damage including liver injury, hepatitis and liver failure. Cases of HLH linked to lamotrigine arise within 1 to 4 weeks of starting the drug, often in infants or children, who present with clinical features of DRESS syndrome or anticonvulsant hypersensitivity syndrome which is then followed by progressive cytopenias, high triglycerides and ferritin accompanied by low fibrinogen levels and bone marrow or liver histology demonstrating hemophagocytosis. Lamotrigine is one of the most common causes of drug-induced HLH syndrome.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of lamotrigine hepatotoxicity is thought to be hypersensitivity or an immunological response to a metabolically generated drug-protein complex. Women, children and patients taking valproic acid appear to be more susceptible. Higher doses and rapid dose escalations have also been linked with higher incidence of lamotrigine hepatotoxicity. Genetic studies have shown little or no association of lamotrigine hepatotoxicity with specific HLA alleles, such as those associated with carbamazepine related hypersensitivity reactions.

### Outcome and Management

Lamotrigine hepatotoxicity is usually rapidly reversible within a few days of the drug being stopped. In cases of multiorgan failure, disseminated intravascular consumption (DIC), rhabdomyolysis and renal failure are common. If lamotrigine is stopped promptly, recovery is expected within one to two weeks. Prolonged exposure after the appearance of symptoms may escalate the injury to result in irreversible, rapidly progressive liver failure. Corticosteroids are frequently used to treat lamotrigine hepatoxicity particularly in the setting of a hypersensitivity reactions such as DRESS or Stephens Johnson syndrome. Cases that do not response to high doses of corticosteroids are often treated with other immunosuppressive agents such as tacrolimus or benralizumab (a monoclonal antibody to IL5 that reduces eosinophil counts) but with uncertain effectiveness. Chronic injury from lamotrigine therapy has not been reported. Lamotrigine is not an aromatic anticonvulsant and is unrelated structurally to phenytoin and carbamazepine. However, some degree of overlap in hypersensitivity response occurs, and patients with hepatotoxicity related to lamotrigine should best avoid exposure to the aromatic anticonvulsants such as phenytoin, phenobarbital, and carbamazepine.

Hemophagocytolytic lymphohistiocytosis caused by lamotrigine can be life-threatening and is usually treated with immunosuppression including a tapering course of dexamethasone and etoposide and occasionally with monoclonal antibody to interferon gamma (emapalumab).

Drug Class: Anticonvulsants

## CASE REPORT

### Case 1. Acute hepatitis-like injury due to lamotrigine.(1)

A 27 year old female with a history of seizure disorder developed a rash with fever, itching, nausea, vomiting and fatigue 3 weeks after starting lamotrigine. The dose had been increased from 50 mg daily to 100 mg daily one week before onset of symptoms. She continued to take lamotrigine for another week before seeking medical attention, when she was found to have elevated serum aminotransferase levels and was admitted to for further evaluation. Physical examination revealed an extensive maculopapular rash and fever but no jaundice. Initially, serum ALT levels were ~25 fold elevated, but serum bilirubin levels were normal. Eosinophil counts were not available. Tests for viral hepatitis, autoimmune hepatitis and ultrasound were unremarkable. The patient had no history of alcohol or drug abuse or previous history of liver disease or drug allergy. After two days in the hospital she became jaundiced with serum bilirubin that eventually rose to 6.4 mg/dL. Over the following days, laboratory test results began to improve and were close to normal 2 weeks later.

#### Key Points

Medication: | Lamotrigine (50→100 mg/day)
Pattern: | Hepatocellular (R=56)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 26 days
Recovery: | Complete after 19 days
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | Lamotrigine started, 50 mg daily
2 weeks | 0 | Lamotrigine increased to 100 mg
3 weeks | 0 | Rash, itching, nausea, vomiting
4 weeks | 0 | 1576 | 79 | 0.4 | Lamotrigine stopped
| 2 days | 5705 | 172 | 4.9
| 3 days | 4160 | 147 | 6.6
| 4 days | 3372 | 129 | 6.4
5 weeks | 5 days | 2460 | 127 | 5.5 | Discharged
7 weeks | 19 days | 74 | 63 | 1.2
Normal Values | | <42 | <115 | <1.2

#### Comment

A typical acute hepatitis-like injury arose after 3 weeks of lamotrigine therapy with somewhat delayed discontinuation. The timing of this reaction and the signs of hypersensitivity including fever and rash support the diagnosis and suggest an immuno-allergic etiology. Therapy with other anticonvulsants may be tolerated but monitoring for evidence of liver injury would be appropriate.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lamotrigine – Generic, Lamictal®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lamotrigine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lamotrigine | 84057-84-1 | C9-H7-C12-N5 | SID: 135013827

## CITED REFERENCE

1 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7.25754159

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2026

Abbreviations used: iv, intravenous; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis; DRESS, drug reaction with eosinophilia and systemic symptoms; HLA, human leukocyte antigen; HLH, hemophagocytic lymphohistiocytosis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; lamotrigine is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury; liver injury due to lamotrigine can be a component of a generalized hypersensitivity reaction and result in a prominent and severe hepatitis which can be fatal).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Cohen AF, Land GS, Breimer DD, Yuen WC, Winton C, Peck AW. Lamotrigine, a new anticonvulsant: pharmacokinetics in normal humans. Clin Pharmacol Ther 1987; 42: 535-41. (Study of healthy volunteers; a minor rise in serum bilirubin was found with iv lamotrigine; not reproduced in later studies; no increase in liver enzymes or GGT). 3677542
Brodie MJ. Lamotrigine. Lancet 1992; 339: 1397-1400. (Review article on lamotrigine; rare side effects mentioned were macropapular rash, angioedema, Stevens-Johnson syndrome [SJS] and acute multiorgan failure). 1350815
Yuen AW, Bihari DJ. Multiorgan failure and disseminated intravascular coagulation in severe convulsive seizures. Lancet 1992; 340: 618. (Letter in response to Brodie review, summarizing 28 reported cases of acute organ failure attributed to lamotrigine, suggesting that these were due to severe convulsive seizures with rhabdomyolysis, disseminated intravascular coagulation, and ischemic injury to multiple tissues including liver).
Schaub JEM, Williamson PJ, Barnes EW, Trewby PN. Multisystem adverse reaction to lamotrigine. Lancet 1994; 344: 481. (45 year old woman developed fever, rash, and multisystem involvement 14 days after starting lamotrigine, with AST 1200 U/L, LDH 6830 U/L, CPK 7770 U/L, myoglobinemia, disseminated intravascular coagulation and renal insufficiency without preceding severe convulsive seizures; no mention of jaundice; resolved in 2 weeks).
Makin AJ, Fitt S, Williams R, Duncan JS. Fulminant hepatic failure induced by lamotrigine. BMJ 1995; 311: 292. (22 year old woman developed fever and rash 3 weeks after starting lamotrigine [2 days after increasing dose] with AST 913 U/L; despite stopping the drug, she went into coma and died; no bilirubin levels or other test results provided).
Sterker M, Berrouschot J, Schneider D. Fatal course of toxic epidermal necrolysis under treatment with lamotrigine. Int J Clin Pharmacol Ther 1995; 33: 595-7. (56 year old man developed rash one week after starting lamotrigine; 2 weeks later, found unconscious with severe necrotizing rash involving 80% of his body [bilirubin 2.1 mg/dL, ALT 529 U/L, LDH 1260 U/L], with disseminated intravascular coagulation, myoglobulinemia, respiratory failure, and subsequent death). 8688983
Sullivan JR, Watson A. Lamotrigine-induced toxic epidermal necrolysis treated with intravenous cyclosporin: a discussion of pathogenesis and immunosuppressive management. Australas J Dermatol. 1996; 37: 208-12. (Review of toxic epidermal necrolysis related to lamotrigine). 8961591
Chattergoon DS, McGuigan MA, Koren G, Hwang P, Ito S. Multiorgan dysfunction and disseminated intravascular coagulation in children receiving lamotrigine and valproic acid. Neurology 1997; 49: 1442-4. (3 year old boy and 11 year old girl developed multiorgan failure while on valproate, arising 9 days after starting lamotrigine, presenting with fever, rash and progressing to disseminated intravascular coagulation, rhabdomyolysis and mild hepatitis [bilirubin normal, ALT 128 and 279 U/L, Alk P normal and 145 U/L], ultimate recovery; concise review of literature). 9371937
Jones D, Chhiap V, Resor S, Appel G, Grossman ME. Phenytoin-like hypersensitivity associated with lamotrigine. J Am Acad Dermatol 1997; 36: 1016-8. (Adult who developed rash after 1 and high fever after 3 weeks of lamotrigine with bilirubin 1.7 mg/dL, ALT 130 U/L; treated with corticosteroids with slow recovery). 9204073
Messenheimer JA. Rash in adult and pediatric patients treated with lamotrigine. Can J Neurol Sci 1998; 25: S14–8. (24 year old man developed rash after 1 week and fever after 3 weeks of lamotrigine therapy [bilirubin 1.7 mg/dL, ALT 130 U/L, Alk P 274 U/L], resolving within 3 weeks on intravenous methylprednisolone; review of rates of rash in clinical trials of lamotrigine found reports of rash in 0.3% of adults and 1% of children; Stevens-Johnson syndrome in 0.1% of adults and 0.5% of children). 9827240
Schlienger RG, Knowles SR, Shear NH. Lamotrigine associated anticonvulsant hypersensitivity syndrome. Neurology 1998; 51: 1172–5. (Review of lamotrigine hypersensitivity cases in the literature up to 1998). 9781550
Gómez Caturla A, Arteta Jiménez M, Fernández Planelles C, Portillo J. [Acute hepatitis associated with lamotrigine administration]. Med Clin (Barc) 1998; 111: 675-6. Spanish. (35 year old man with Down syndrome treated with valproate and carbamazepine for many years, developed fatigue and abdominal pain 6 weeks after starting lamotrigine [bilirubin 10.0 mg/dL, ALT 732 U/L, Alk P 418 U/L, 16% eosinophils], with signs of hepatic failure but ultimate full recovery)
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489– 501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after starting anticonvulsant; liver being most common internal organ involved; occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs that can be involved include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed). 10612272
Arnon R, DeVivo D, Defelice AR, Kazlow PG. Acute hepatic failure in a child treated with lamotrigine. Pediatr Neurol 1998; 18: 251–2. (8 year old boy developed fever after 2-3 weeks of lamotrigine, followed by jaundice [bilirubin 14.3 mg/dL, ALT 5218 U/L, Alk P 234 U/L, elevated INR, ammonia, and high lamotrigine levels], rapid improvement with stopping). 9568923
Fayad M, Choueiri R, Mikati M. Potential hepatotoxicity of lamotrigine. Pediatr Neurol 2000; 22: 49–52. (3 children, ages 3, 4 and 10 years, developed liver injury after 1, 2 and 6 weeks of lamotrigine therapy [bilirubin levels not reported, ALT 612, 257 and 291 U/L; Alk P 152, 344 and 254 U/L], resolving rapidly with stopping; one child also had a rash). 10669206
Sauvé G, Bresson-Hadni S, Prost P, Le Calvez S, Becker M-C, Galmiche J, Carbillet J-P, Miguet J-P. Acute hepatitis after lamotrigine administration. Dig Dis Sci 2000; 45:1874–7. (28 year old woman developed fever and rash 14 days after starting lamotrigine [bilirubin 1.7 mg/dL, ALT 503 U/L, and Alk P 287 U/L], with drowsiness, fever, and abnormal protime, but rapid recovery after stopping). 11052335
Wong IC, Lhatoo SD. Adverse reactions to new anticonvulsant drugs. Drug Saf 2000; 23: 35-56. (Review of adverse events associated with lamotrigine reported in the literature). 10915031
Schaub N, Bircher AJ. Severe hypersensitivity syndrome to lamotrigine confirmed by lymphocyte stimulation in vitro. Allergy 2000; 55: 191–3. (36 year old man developed rash and fever after 4 weeks of lamotrigine and valproate therapy, but no mention of hepatic involvement; positive lymphocyte stimulation). 10726736
Lambotte O, Costedoat-Chalumeau N, Amoura Z, Piette JC, Cacoub P. Drug-induced hemophagocytosis. Am J Med. 2002;112:592-3. (Description of two cases of drug-induced hypersensitivity syndrome due to vancomycin and TMP/SMZ that was followed by cytopenias and hemophagocytosis on bone marrow biopsy). 12015259
Overstreet K, Costaanza C, Behling C, Hassanin T, Masliah E. Fatal progressive hepatic necrosis associated with lamotrigine treatment: a case report and literature review. Dig Dis Sci 2002; 47: 1921-5. (35 year old woman developed fever, rash and abdominal pain after 5 weeks of lamotrigine therapy with ALT 560 U/L on admission, drug continued for a few days, and liver tests worsened [peak bilirubin 10.3 mg/dL, ALT 2485 U/L, Alk P 815 U/L], followed by progressive hepatic failure and death, autopsy showed massive necrosis). 12353830
Bin-Nakhi HA, Sadeq S, Pinto RG, Habeeb Y. Anticonvulsant hypersensitivity syndrome: report of 2 cases from Kuwait. Med Princ Pract 2003; 12: 197-9. (Child with rash, fever and lymphadenopathy 2 weeks after starting lamotrigine with pancytopenia, eosinophilia, atypical lymphocytes [bilirubin 1.1, ALT 104 U/L, Alk P 104 U/L], resolving within 3 weeks of switching to clonazepam). 12766341
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine but none to lamotrigine or other anticonvulsants). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 1 was attributed to phenytoin, 1 to valproate and 1 to carbamazepine, but none to lamotrigine or other anticonvulsants). 16165719
Mecarelli O, Pulitano P, Mingoia M, Ferretti G, Rossi M, Berloco PB, Muda AO. Acute hepatitis associated with lamotrigine and managed with the molecular adsorbents recirculating system (MARS). Epilepsia 2005; 46:1687-9. (30 year old woman developed fever, rash and jaundice 20 days after starting lamotrigine [bilirubin 14 mg/dL, ALT 7268 U/L, INR 2.4 and hepatic encephalopathy], resolving within 3-4 weeks of stopping lamotrigine despite therapy with MARS). 16190944
Chang CC, Shiah IS, Yeh CB, Wang TS, Chang HA. Lamotrigine associated anticonvulsant hypersensitivity syndrome in bipolar disorder. Prog Neuropsychopharmacol Biol Psychiatry 2006; 30: 741-4. (48 year old woman developed fever and rash ~10 days after starting lamotrigine for bipolar illness and subsequently had pneumonitis, hepatitis [ALT 174 U/L, but no other results given] and bone marrow suppression, resolving rapidly once lamotrigine was stopped; valproate and venlafaxine later restarted without difficulty). 16442685
Fix OK, Peters MG, Davern TJ. Eosinophilic hepatitis caused by lamotrigine. Clin Gastroenterol Hepatol 2006; 4: xxvi. (20 year old woman developed pneumonitis, jaundice and rash 6 weeks after starting lamotrigine [bilirubin 10.4 mg/dL, ALT 233 U/L, Alk P 171 U/L, eosinophils 15%], no follow up provided).
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of fatal drug induced liver injury: phenytoin was the only anticonvulsant within the 19 most common causes, ranking 12th [57 cases]). 16054882
Petkov T, Pehlivanov G, Grozdev I, Kavaklieva S, Tsankov N. Toxic epidermal necrolysis as a dermatological manifestation of drug hypersensitivity syndrome. Eur J Dermatol 2007; 17: 422-7. (3 cases of toxic epidermal necrolysis, one in a 28 year old man who developed facial edema and rash progressing to severe exfoliation 1 week after adding lamotrigine to long term valproate therapy [bilirubin 0.6 mg/dL, ALT 50 U/L, GGT 48 U/L, eosinophils 10%], resolving with corticosteroid therapy). 17673387
Gerstner T, Bauer MO, Longin E, Bell N, Koenig SA. Reversible hepatotoxicity, pancreatitis, coagulation disorder and simultaneous bone marrow suppression with valproate in a 2-year-old girl. Seizure 2007; 16: 554-6. (2 year old girl with suspected valproate hepatotoxicity, liver abnormalities improved on withdrawal of valproate, despite continuation of lamotrigine and topiramate). 17493839
Moeller KE, Wei L, Jewell AD, Carver LA. Acute hepatotoxicity associated with lamotrigine. Am J Psychiatry 2008; 165: 539-40. (21 year old man being treated with lamotrigine for bipolar disorder and schizophrenia was found to have ALT 347 U/L without fever or jaundice and recovered within 7 days of stopping). 18381923
Delima SI, Walsh LE, Golomb MR. Simultaneous toxicities in a child on multiple anticonvulsants. J Child Neurol. 2008; 23: 1054-7. (3 year old girl with epilepsy on valproate, lamotrigine and phenytoin for unstated period developed fever, cough and liver test abnormalities [bilirubin not given, ALT 7390 U/L, Alk P 381, INR 1.26], and mild bone marrow insufficiency; all 3 drugs were stopped and liver abnormalities resolved, evidently able to tolerate lamotrigine without problems later). 18344455
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand 2008; 118: 281-90. (Review of liver injury due to anticonvulsants including lamotrigine: fatal cases of lamotrigine injury have been reported, usually arising within 3 weeks of starting therapy, often while receiving other anticonvulsants and in context of hypersensitivity syndrome). 18341684
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, and gabapentin and topiramate 1 each). 18955056
Su-Yin AN, Tai WW, Olson KR. Lamotrigine-associated reversible severe hepatitis: a case report. J Med Toxicol 2008; 4: 258-60. (43 year old woman developed rash and serum enzyme elevations 2 weeks after starting lamotrigine [bilirubin 0.4 rising to 3.9 mg/dL, ALT 2490 U/L, Alk P 93 U/L], which worsened for several days but then improved and resolved completely within 1 month of stopping). 19031378
Aouam K, Ben Romdhane F, Loussaief C, Salem R, Toumi A, Belhadjali H, Chaabane A, et al. Hypersensitivity syndrome induced by anticonvulsants: possible cross-reactivity between carbamazepine and lamotrigine. J Clin Pharmacol 2009; 49: 1488-91. (14 year old boy developed facial edema and fever 6 weeks after starting carbamazepine [bilirubin not given, ALT 193 U/L, eosinophils 15%], which resolved with stopping, and months later he developed fever, rash and pneumonitis 7 weeks after starting lamotrigine [ALT 154 U/L, eosinophils 12%], resolving upon stopping). 19723672
Amante MF, Filippini AV, Cejas N, Lendoire J, Imventarza O, Parisi C. Dress syndrome and fulminant hepatic failure induced by lamotrigine. Ann Hepatol 2009; 8: 75-7. (21 year old woman developed fever and sore throat within 18 days of starting lamotrigine which progressed to desquamation, jaundice and pruritus with subsequent hepatic failure and emergency liver transplant, the explant showing submassive, confluent necrosis). 19221540
Ouellet G, Tremblay L, Marleau D. Fulminant hepatitis induced by lamotrigine. South Med J 2009; 102: 82-4. (40 year old woman developed fever 12 days after starting lamotrigine followed by rash and jaundice [bilirubin 1.6 rising to 12.2 mg/dL, ALT 9600 U/L, Alk P not available, INR 5.7], but eventual spontaneous resolution without corticosteroids within 10 weeks). 19077780
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contains 9036 hepatic adverse drug reactions in children; lamotrigine accounted for 112 cases [1.2%: ranking 7th], yielding an adjusted relative risk odds ratio of 2.2). 21039766
An DM, Wu XT, Hu FY, Yan B, Stefan H, Zhou D. Association study of lamotrigine-induced cutaneous adverse reactions and HLA-B*1502 in a Han Chinese population. Epilepsy Res 2010; 92: 226-30. (Among 25 Chinese patients with cutaneous adverse reactions to lamotrigine, 4 [16%] had HLA-B*15:02 compared to 8.5% of lamotrigine tolerant controls). 21071176
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 11 of which were due to anticonvulsants, but none to lamotrigine). 20949552
Shi YW, Min FL, Liu XR, Zan LX, Gao MM, Yu MJ, Liao WP. HLA-B alleles and lamotrigine-induced cutaneous adverse drug reactions in the Han Chinese population. Basic Clin Pharmacol Toxicol 2011; 109: 42-6. (Among 2 Chinese patients with lamotrigine associated Stevens Johnson syndrome, neither had HLA-B*15:02 and rates in those with less severe skin hypersensitivity reactions were not elevated). 21306565
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; for the Drug-Induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3 and valproate in 3], none of which were fatal or led to chronic injury). 21788760
Bakker CV, Hegt VN, Praag MC. Lamotrigine hypersensitivity syndrome and spiking Fever. Indian J Dermatol 2012; 57: 504. (24 year old woman developed fever and rash 4 weeks after starting lamotrigine [bilirubin not given, ALT 236 U/L, Alk P 215 U/L], fever and liver injury resolving with prednisone therapy).
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (DRESS syndrome is marked by triad of fever, rash and internal organ involvement, usually liver; while lamotrigine is not an aromatic anticonvulsant, it has been linked to cases of DRESS and Stevens Johnson syndrome). 22794330
Neuman MG, Cohen L, Nanau RM, Hwang PA. Genetic and immune predictors for hypersensitivity syndrome to antiepileptic drugs. Transl Res 2012; 159: 397-406. (Review of hypersensitivity reactions to antiepileptic agents including lamotrigine and lymphocyte toxicity assays). 22500513
Sato T, Kuniba H, Matsuo M, Matsuzaka T, Moriuchi H. [Case of drug-induced hypersensitivity syndrome due to lamotrigine: demonstration of sequential reactivation of herpesviruses]. No To Hattatsu 2012; 44: 69-72. Japanese. (Abstract: 14 year old girl developed fever, rash, eosinophilia and "liver dysfunction" during lamotrigine therapy, with relapsing course and hypothyroidism). 22352035
Bhayana H, Appasani S, Thapa BR, Das A, Singh K. Lamotrigine-induced vanishing bile duct syndrome in a child. J Pediatr Gastroenterol Nutr 2012; 55: e147-8. (12 year old boy developed rash 2 weeks after starting lamotrigine followed by jaundice 2 weeks later [bilirubin 14.8 mg/dL, ALT 321 U/L, Alk P 123 U/L], which progressed to vanishing bile duct syndrome and referral for liver transplant within a year of onset [had history of rash after carbamazepine]). 22008955
Hassan I. HLA-B*1502 screening in carbamazepine and lamotrigine candidates of Asian background. Aust N Z J Psychiatry 2012; 46: 1106-7. (Letter expressing opinion that HLA-B*1502 screening should also be used for Asian patients planning to take lamotrigine).
McCormack M, Urban TJ, Shianna KV, Walley N, Pandolfo M, Depondt C, Chaila E, et al. Genome-wide mapping for clinically relevant predictors of lamotrigine- and phenytoin-induced hypersensitivity reactions. Pharmacogenomics 2012; 13: 399-405. (Genome wide association studies failed to identify any significant variation [including HLA-A*3101, previously associated with carbamazepine reactions in Europeans] associated with hypersensitivity to lamotrigine [n=46] or phenytoin [n=44]). 22379998
Patel PP, Gandhi AM, Desai CK, Desai MK, Dikshit RK. An analysis of drug induced Stevens-Johnson syndrome. Indian J Med Res 2012; 136: 1051-3. (59 cases of drug induced Stevens Johnson syndrome were seen at a single referral center in India between 2005-2010, 25% in children, arising 1-39 days after starting drug, major causes being phenytoin [18] and nevirapine [13], 2 were attributed to lamotrigine). 23391805
Biton V, Shneker BF, Naritoku D, Hammer AE, Vuong A, Caldwell PT, Messenheimer JA. Long-term tolerability and safety of lamotrigine extended-release: pooled analysis of three clinical trials. Clin Drug Investig 2013; 33: 359-64. (Pooled analysis of adverse events in 662 patients treated with extended release lamotrigine in 3 controlled trials, found no "clinically important" differences in clinical chemistry results between lamotrigine and placebo recipients).
Cheung YK, Cheng SH, Chan EJ, Lo SV, Ng MH, Kwan P. HLA-B alleles associated with severe cutaneous reactions to antiepileptic drugs in Han Chinese. Epilepsia. 2013;54(7):1307-14. (HLA-B*15:02 was found in 24 of 26 [92%] Chinese patients with carbamazepine related, but only 2 of 6 [33%] with lamotrigine related Stevens Johnson syndrome versus 12% of controls). 23692434
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Drugs of choice for epilepsy; mentions that the adverse effects of lamotrigine include acute hepatitis and Stevens Johnson syndrome; erratum in Treat Guidel Med Lett. 2013;11:112, dosage error in article text). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 3 attributed to anticonvulsants: phenytoin 2 and gabapentin 1, but none attributed to lamotrigine). 23419359
Kaur S, Dogra A. Toxic epidermal necrolysis due to concomitant use of lamotrigine and valproic Acid. Indian J Dermatol 2013; 58: 406. (Two Indian patients with epilepsy on long term valproate developed toxic epidermal necrolysis 2 and 4 weeks after starting lamotrigine, with fever and skin rash involving 30% and 60% of the body surface area [no mention of liver test abnormalities], resolving ultimately with prednisolone therapy).
Parveen S, Javed MA. Stevens Johnson Syndrome associated with Lamotrigine. Pak J Med Sci 2013; 29: 1450-2. (58 year old Pakistani woman developed conjunctivitis, facial swelling and rash 4-6 weeks after starting lamotrigine for depression, resolving within 2 weeks of stopping; no mention of liver test abnormalities). 24550973
Błaszczyk B, Szpringer M, Czuczwar SJ, Lasoń W. Single centre 20 year survey of antiepileptic drug-induced hypersensitivity reactions. Pharmacol Rep 2013; 65: 399-409. (Among 300 patients with epilepsy seen over a 10 year period at a single center in Poland, 30 developed skin rash on anticonvulsant therapy, most commonly with carbamazepine [20 of 130], phenytoin [13 of 40], lamotrigine [13 of 53] and oxcarbazepine [4 of 26]; a single case of Stevens Johnson syndrome was attributed to carbamazepine). 23744424
Ginory A, Chaney-Catchpole M, Demetree JM, Mayol Sabatier LM, Nguyen M. Drug reaction with eosinophilia and systemic symptoms (DRESS) in an adolescent treated with lamotrigine. J Pediatr Pharmacol Ther 2013; 18: 236-40. (17 year old female developed rash, fever, fatigue and then jaundice within 3 weeks of starting lamotrigine for bipolar II disorder [bilirubin 6.5 mg/dL, ALT 2076 U/L, Alk P 455 U/L, mild eosinophilia], improving with stopping and high-dose corticosteroid therapy). 24052787
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants but none to lamotrigine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 9 [1%] due to lamotrigine, the second most common anticonvulsant cause [after phenytoin]). 25754159
Sultan SJ, Sameem F, Ashraf M. Drug reaction with eosinophilia and systemic symptoms: manifestations, treatment, and outcome in 17 patients. Int J Dermatol 2015; 54: 537-42. (Among 17 patients with DRESS or drug-hypersensitivity syndrome seen at a single Indian medical center over a 4 year period, 11 were associated with anticonvulsant therapy including 6 attributed to phenytoin, 2 to phenobarbital, and 1 each to carbamazepine, oxcarbazepine and lamotrigine; all had ALT elevations and 65% were jaundiced). 24738653
Gauchan D, Shaaban H, Parikh N, Chang NL, Altheeb Z, Maroules M. Severe hemophagocytic lymphohistiocytosis as a complication of drug-induced hypersensitivity syndrome. Int J Crit Illn Inj Sci. 2015;5:60-1. (24 year old black woman developed back pain, fever, rash, and sore throat 2 weeks after a single dose of amoxicillin/clavulanate with lymphadenopathy and progressive respiratory failure, anemia, thrombocytopenia, liver injury [bilirubin 150/17 mg/dL, ALT 450 U/L] hypertriglyceridemia, hypofibrinogenemia, and bone marrow with hemophagocytosis). 25810969
Mehrholz D, Urban AE, Herstowska M, Nowicki R, Cubała W, Barańska-Rybak W. A retrospective study of DRESS - drug reaction with eosinophilia and systemic symptoms. Psychiatr Pol 2017; 51: 1079-93. (Among 261 adults with cutaneous drug reactions seen at a single Polish medical center between 2004 and 2017, 10 met criteria for DRESS syndrome, including 6 attributed to carbamazepine, 1 oxycarbamazepine and 2 lamotrigine). 29432504
Han SH, Hur MS, Youn HJ, Roh NK, Lee YW, Choe YB, Ahn KJ. Drug reaction with eosinophilia and systemic symptom syndrome induced by lamotrigine. Ann Dermatol 2017; 29: 206-9. (47 year old Korean man developed rash followed by fever 3 weeks after starting lamotrigine [bilirubin 1.4 mg/dL, ALT 66 U/L, Alk P 148 U/L, eosinophils 28%], responding to methylprednisolone therapy). 28392649
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of newly approved agents including lamotrigine, which causes hepatocellular injury in 1-5 of 10,000 treated patients, typically with features of hypersensitivity and cutaneous signs and which can lead to fatal acute liver failure). 27842767
Vidaurre J, Gedela S, Yarosz S. Antiepileptic drugs and liver disease. Pediatr Neurol 2017; 77: 23-36. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin; lamotrigine is problematic in that it is metabolized largely in the liver, has a high potential of drug interactions and requires dose adjustments for patients with moderate or severe cirrhosis). 29097018
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-130. (Concise review of drugs available for therapy of epilepsy; mentions that lamotrigine is a drug of choice for partial and generalized seizures and atypical, absence, myoclonic and atonic seizures and that adverse events include hepatitis, acute liver failure and Stevens Johnson syndrome). 28746301
Comparison table: some oral antiepileptic drugs. Med Lett Drugs Ther 2017; 59 (1521): e130-e136. (Table of the major oral antiepileptic drugs in current use and listing of oral formulations, usual dosages, adverse effects, drug interactions, current indications and costs). 28746302
Ignaszewski M, Ignaszewski MJ, Kohlitz P. Lamotrigine-associated hemophagocytic lymphohistiocytosis. Am J Ther. 2017;24:e493. . (26 year old man with mood disorder developed fatigue, fever, and bruising shortly after starting lamotrigine with pancytopenia [bilirubin 1.6 mg/dL, ALT 128 U/L, Alk P not given, INR 2.5] and other abnormalities indicative of HLH including fibrinogen <60 and ferritin 44,472 [no units provided] that responded to discontinuation of lamotrigine and treatment with etoposide and dexamethasone). 28005556
Iriki H, Ouchi T, Ito H, Sawada M, Mukai M, Nomura H, Baba Y, et al. Case of lamotrigine-induced drug adverse reaction under tocilizumab treatment with clinical and virological features of drug-induced hypersensitivity syndrome. J Dermatol 2018; 45: 738-41. (29 year old woman with rheumatoid arthritis on tocilizumab [anti-IL6] developed rash, fever and lymphadenopathy 3 weeks after starting lamotrigine, responding to corticosteroid therapy but with mild transient ALT elevations [~120 U/L] and recurrence of rash on three occasions). 29569382
Tawhari I, Tawhari F, Aljuaid M. Lamotrigine-induced drug reaction with eosinophilia and systemic symptoms (DRESS) during primary Epstein-Barr virus (EBV) infection. BMJ Case Rep 2018; 2018. pii: bcr-2017-222416. (21 year old man developed fever, sore throat, rash and abdominal pain 2 weeks after starting lamotrigine [bilirubin not given, ALT 506 U/L, Alk P 246 U/L, 10% atypical lymphocytes and positive heterophile antibody], resolving within 3 weeks on methylprednisolone therapy).
In brief: A potentially fatal immune reaction to lamotrigine. Med Lett Drugs Ther 2018; 60 (1549): 105. (Brief summary of FDA warning of possible complication of lamotrigine therapy of hemophagocytic lymphohistiocytosis [HLH], based upon 8 cases reported to the agency arising within 24 days of starting lamotrigine). 29913474
Büyüköztürk S, Kekik Ç, Gökyiğit AZ, Tezer Filik FI, Karakaya G, Saygi S, Dursun AB, et al. Cutaneous drug reactions to antiepileptic drugs and relation with HLA alleles in the Turkish population. Eur Ann Allergy Clin Immunol. 2018;50:36-41. (Among 40 Turkish patients with hypersensitivity reactions to anticonvulsant medications, 11 were attributed to lamotrigine and 10 to carbamazepine; with HLA-testing, no alleles were linked with DRESS or SJS syndrome or with lamotrigine, although HLA-B*35:02 was overrepresented overall in the group with hypersensitivity reactions compared to controls). 29350020
Tawhari I, Tawhari F, Aljuaid M. Lamotrigine-induced drug reaction with eosinophilia and systemic symptoms (DRESS) during primary Epstein-Barr virus(EBV) infection. BMJ Case Rep. 2018;2018:bcr2017222416. (21 year old man developed fever, rash, sore throat, facial edema, nausea, and abdominal pain 2 weeks after starting lamotrigine for chronic anxiety [bilirubin not given, ALT 506 U/L, Alk P 246 U/L, positive heterophile, 10% atypical lymphocytes, and IgM anti-EBV] which suggested acute mononucleosis rather than drug-induced liver injury, and symptoms and laboratory abnormalities resolved with a 3 week course of corticosteroids). 29367368
Hancock CL, Gálvez A. Lamotrigine-associated hemophagocytic lymphohistiocytosis. Blood. 2019;133:1165. (47 year old man with epilepsy developed fever, rash and liver test abnormalities within a few days of starting lamotrigine that was followed by leukopenia, thrombocytopenia and bone marrow biopsy demonstrating hemophagocytosis). 30846511
Zhou JY, Martinez JA, Shen JP. Lamotrigine-induced hemophagocytic lymphohistiocytosis with Takotsubo cardiomyopathy: a case report. J Med Case Rep. 2019;13:345. (45 year old woman developed high fevers 17 days after starting lamotrigine for depression developing anemia, thrombocytopenia, elevations in AST [151 rising to 3000 U/L], ferritin [29,101 rising to >100,000 ng/mL], triglycerides [rising to >3000 mg/dL] and bone marrow demonstrating hemophagocytosis, responding to etoposide and a ten-week course of dexamethasone). 31767022
Tashiro Y, Azukizawa H, Asada H, Niihara H, Morita E, Yamauchi T, Mizukawa Y, et al. Drug-induced hypersensitivity syndrome/drug reaction with eosinophilia and systemic symptoms due to lamotrigine differs from that due to other drugs. J Dermatol. 2019;46:226-233. . (Among 44 cases of drug-induced DRESS syndrome seen at 3 Japanese referral centers, the 12 due to lamotrigine were on average milder than those from other agents with lower mean ALT levels [111 vs 328 U/L] and atypical lymphocytosis [3% vs 10%] although skin biopsy histology was similar [no mention of bilirubin or INR levels]). 30663091
Singh T, Niazi M, Karri K, Rudikoff D, Gonzalez E. A Rare Case of DRESS (Drug Reaction with Eosinophilia and Systemic Symptoms) Syndrome with cholecystitis in a patient on levetiracetam. Cureus. 2019;11:e4245. (36 year old woman with brain cancer and seizures developed fever, rash, facial edema, and abdominal pain 11 weeks after starting levetiracetam and 4 weeks after addition of lamotrigine [bilirubin not given, ALT 1731 U/L, Alk P 302 U/L] who did not improve with stopping lamotrigine but did 10 days later when levetiracetam was stopped). 31131168
Park CS, Kang DY, Kang MG, Kim S, Ye YM, Kim SH, Park HK, et al.; Korean Registry of Severe Cutaneous Adverse Reactions Consortium. Severe cutaneous adverse reactions to antiepileptic drugs: a nationwide registry-based study in Korea. Allergy Asthma Immunol Res. 2019;11:709-722. (Among 161 patients with anticonvulsant induced severe cutaneous adverse reactions [SJS/TEN in 72, DRESS in 89] enrolled in a Korean National registry database between 2010 and 2015, the major causes were carbamazepine, lamotrigine, valproate and phenytoin with ALT elevations arising in 51% [median peak ALT 187 U/L] with SJS vs in 76% [median peak ALT 437 U/L] with DRESS). 31332981
Lameiras C, Ornelas É, Mendes Lopes M, Dória MDC. Drug reaction with eosinophilia and systemic symptoms syndrome in a patient taking lamotrigine. BMJ Case Rep. 2019;12:e229180. Corrected and republished in: Drug Ther Bull. 2020;58:93-95. 31653619 (50 year old man with epilepsy developed fever and rash 4 weeks after lamotrigine was added to chronic valproate therapy but was initially without eosinophilia or liver test abnormalities, but several days later despite stopping lamotrigine he had worsening symptoms, eosinophilia of 35%, and slight elevations in ALT [156 U/L] but normal bilirubin and alkaline phosphatase; symptoms and test abnormalities eventually resolving with corticosteroid therapy).
Suleman N, Ozdemirli M, Weisman D. Lamotrigine-associated hemophagocytic lymphohistiocytosis. BMJ Case Rep. 2021;14:e238183. (31 year old man with attention deficit hyperactivity disorder [ADHD] developed fever, rash, nausea, headache, and jaundice 2 weeks after starting lamotrigine [bilirubin 7.1 mg/dL, ALT 3216 U/L, Alk P 277 U/L, ferritin >40,000 ng/mL, decreased fibrinogen, and hemophagocytosis on bone marrow biopsy], which resolved within 2 months of starting dexamethasone). 33408106
Kamitaki BK, Minacapelli CD, Zhang P, Wachuku C, Gupta K, Catalano C, Rustgi V. Drug-induced liver injury associated with antiseizure medications from the FDA Adverse Event Reporting System (FAERS). Epilepsy Behav. 2021;117:107832. (Among 2175 spontaneous reports of anticonvulsant-induced liver injury made to the FDA’s Adverse Event Reporting System between 2018 and 2020, the most frequently implicated agents were levetiracetam [380], pregabalin [372], lamotrigine [317], valproate [264], carbamazepine [225], diazepam [201], gabapentin [191], and phenytoin [126]). 33626490
Chalasani N, Bonkovsky HL, Stine JG, Gu J, Barnhart H, Jacobsen E, Björnsson E, et al.; Drug-Induced Liver Injury Network (DILIN) Study Investigators. Clinical characteristics of antiepileptic-induced liver injury in patients from the DILIN Prospective Study. J Hepatol. 2022;76:832-840. (Among 1,711 cases of drug induced liver injury enrolled in a prospective US study between 2004 and 2020, 66 [4%] were due to anticonvulsants including 18 due to lamotrigine, 16 phenytoin, 11 carbamazepine, 10 valproate, 4 gabapentin, and 7 miscellaneous others; the lamotrigine cases were 83% female, 22% African American; 67% with fever, 72% rash, 24% eosinophilia, 72% DRESS; with median initial ALT 1699 U/L, Alk P 357 U/L, bilirubin 10 mg/dL, INR 1.3; and while 6 cases were severe, none were fatal or required liver transplantation). 34953957
Deng J, Fu ZR, Wang L, Liu J, Chen CH, Fang F, Wang XL. Acute liver failure associated with lamotrigine in children with epilepsy: A report of two cases and thoughts on pharmacogenomics. Epilepsy Behav Rep. 2022;20:100568. (Two Chinese children, ages 3 and 13 years, developed fever, rash, and severe liver injury 7 and 10 days after lamotrigine was added to a regimen of valproate and clonazepam for refractory epilepsy, one dying of hepatic failure within a few days of presentation and the other ultimately recovering after medical management). 36345310
Khan Z, Warrier V, Muhammad SA, Gupta A, Yousif Y, Khan A, Afghan A, et al. Drug reaction with eosinophilia and systemic symptoms syndrome in a patient taking lamotrigine: a case report based literature review. Cureus. 2022;14:e22359. (29 year old man with bipolar disorder developed fever, rash, lymphadenopathy, eosinophilia, and liver test abnormalities two weeks after starting lamotrigine [bilirubin 3.2 mg/dL, ALT 1788 U/L, Alk P 45 U/L, INR 1.7] with response to corticosteroids and resolution of symptoms within a month). 35371713
Abdelnabi M, Elmassry M, Sekhon J, Benjanuwattra J. Acute onset of fever, eosinophilia, rash, acute kidney injury, and a positive monospot test in a patient on lamotrigine: DRESS syndrome. Lancet. 2022;399(10338):1902. (20 year old woman developed rash, fever, myalgias, edema, and dyspnea shortly after increasing her dose of lamotrigine for bipolar disorder [ALT 79 U/L, bilirubin and alkaline phosphatase not given, creatinine 5.9, monospot positive but anti-EBV results not given], all symptoms and laboratory abnormalities resolving with corticosteroid therapy). 35569467
Vrhovski D, Ikić Matijašević M, Nesek Adam V. Drug-induced hypersensitivity syndrome caused by lamotrigine, a case report. Acta Clin Croat. 2022;61(Suppl 1):88-92. (52 year old woman developed high fever, rash, and facial edema 2 days after starting lamotrigine for a psychiatric condition with elevations in serum aminotransferase levels and eosinophilia [specific results not provided] and ultimately responding to corticosteroid therapy). 36304802
Krivda LK, Campagna LJ, Mignano MS, Cho CS. Prolonged drug-induced hypersensitivity syndrome/dress with alopecia areata and autoimmune thyroiditis. Fed Pract. 2022;39:350-354. (35 year old Filipino woman developed rash 5 weeks after starting and 1 week after increasing the dose of lamotrigine for bipolar disorder, with a rapid response to corticosteroids but repeated relapses when the dose was reduced finally resolving and able to stop corticosteroids after 5 months of therapy, but 4 months later she represented with alopecia and Hashimoto’s thyroiditis). 36425806
Clark A, St Clair B. Severe cutaneous adverse reactions associated with high-dose lamotrigine for mood disorders: a case series. Innov Pharm. 2022;13:. 10.24926/iip.v13i2.4541 (Two patients, a 35 year old man and a 46 year old woman, presented with severe cutaneous reactions [SJS and DRESS] 2 and 3.5 weeks after starting lamotrigine in a dose of 100 mg twice daily, and both had a prolonged and severe course and were left with chronic disability; supporting the heighten risk of severe outcomes with excessive starting doses). 36654707
Doan KD, Akinsanya A, Kuhar M, Mesa H. Fatal eosinophilic myocarditis and submassive hepatic necrosis in lamotrigine induced DRESS syndrome. Allergy Asthma Clin Immunol. 2023;19:92. (39 year old woman developed generalized rash, lymphadenopathy, eosinophilia, and liver test abnormalities [ALT 555 U/L, bilirubin and alkaline phosphatase not given] 5 days after lamotrigine was increased from 75 to 100 mg daily; the symptoms improving with prednisone therapy but then recurred and she died suddenly 5 days later, autopsy showing severe eosinophilic myocarditis and submassive hepatic necrosis). 37880699
Couper MR, Brown RM, Nath S, Parida A, Kelgeri C. Periportal necrosis and successful liver transplantation following lamotrigine drug-induced liver injury in a child. BMJ Case Rep. 2023;16:e255787. (A girl in “middle childhood” with ADHD developed lethargy and vomiting 3 weeks after starting lamotrigine [bilirubin 7.9 mg/dL, ALT 9067 U/L, Alk P 286 U/L, INR 4.9] developed worsening neurologic status and undergoing successful liver transplantation 6 days after presentation). 38000812
Medina-Cáliz I, Sanabria-Cabrera J, Villanueva-Paz M, Aukštikalnė L, Stephens C, Robles-Díaz M, Pinazo-Bandera JM, et al. Characterization of drug-induced liver injury associated with drug reaction with eosinophilia and systemic symptoms in two prospective DILI registries. Arch Toxicol. 2024;98:303-325. (Among 53 cases of DRESS syndrome identified in Spanish and Latin American prospective registries, the most common causes were carbamazepine [7], anti-tuberculosis agents [7], amoxicillin-clavulanate [6], allopurinol [4], and lamotrigine [4]; DRESS cases tended to the cholestatic or mixed in pattern [56%]). 38051367
Prechal D, Arntzen D, Klaas L, Paulmann M, Mockenhaupt M, Thimme R, Schuchmann M. DRESS als seltene Differentialdiagnose bei Eosinophilie, Hautexanthem und akuter Hepatitis [DRESS as a rare differential diagnosis in eosinophilia, skin rash and acute hepatitis]. Z Gastroenterol. 2024;62:2056-2060. German. 38749459 (21 year old woman developed fever, sore throat, lymphadenopathy, rash, eosinophilia, and hepatitis 4 weeks after starting lamotrigine for bipolar illness [laboratory values not provided]).
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including lamotrigine at an estimate rate of 1 per 10,000 persons per year of exposure). 38913369
Wang H, Peng J, Zeng W, Pan X. Lamotrigine-induced hemophagocytic lymphohistiocytosis with DRESS. Clin Lab. 2024;70. . (A 33 year old woman with epilepsy developed facial swelling, fever, rash, tingling, jaundice and pruritus accompanied by anemia and thrombocytopenia, 3 weeks after starting lamotrigine [bilirubin 34.9 mg/dL, ALT 1872, AST 957 U/L] with hypofibrinogenemia, elevated ESR, high ferritin, and decrease in NK cell activity compatible with HLH with some manifestations of DRESS syndrome). 38345991
Moshayedi MA, Asilian A, Mokhtari F. Evaluation of severe adverse cutaneous drug reactions in patients admitted to tertiary care center: A cross-sectional study. Health Sci Rep. 2024;7:e1969. (Among 195 patients presenting with severe cutaneous drug reactions to a single Iranian referral center between 2013 and 2019, 33 [17%] were due to lamotrigine including 8 with DRESS, 14 SJS, 6 TEN, and only 2 deaths). 38486684
Demas N, Shaikh MB. Amoxicillin and lamotrigine-induced DRESS syndrome: A case report. Clin Case Rep. 2024;12:e9487. (18 year old Hispanic female developed DRESS with diffuse rash, fever, facial edema, and abdominal pain 4 weeks after increasing her dose of lamotrigine given for mood disorder [but also having recently had a transient rash after 3 days of amoxicillin] with bilirubin 2.0 mg/dL, ALT 407 U/L, Alk P 320 U/L, atypical lymphocytosis, resolving with corticosteroid therapy). 39434770
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of drug-induced liver injury enrolled in a prospective Latin American database between 2011 and 2020, 4 [1%] were attributed to lamotrigine). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916 (Among 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2004 and 2024, 13 cases [1%] were attributed to lamotrigine being the 16th most frequently implicated drug and occurring at an estimated rate of 1 per 2,300 persons treated).
Rahnama-Moghadam S, Arora N, Vuppalanchi R, Li YJ, Gu J, Barnhart H, Phillips E, Chalasani N; Drug Induced Liver Injury Network. DRESS syndrome in patients with drug-induced liver injury: characteristics and HLA risk factors. Am J Gastroenterol. 2025 Jun 12:. 10.14309/ajg.0000000000003590 (Among 2,121 patients with drug-induced liver injury enrolled in a US prospective registry between 2004 and 2023, 128 presented with DRESS syndrome, the most common causes being TMP/SMZ [n=20 of 105 total cases: 19%], lamotrigine [13 of 20: 65%], phenytoin [10 of 22: 46%], allopurinol [7 of 12: 58%], and carbamazepine [5 of 12: 42%]). 40504263
Ross KR, Horesh E, Fang MM, Keller JJ. Benralizumab in corticosteroid-refractory drug reaction with eosinophilia and systemic symptoms: a case report. Cureus. 2025;17:e86932. (20 year old man with epilepsy developed rash, fever, facial edema, lymphadenopathy, and rising liver test abnormalities 3 weeks after starting lamotrigine [bilirubin rising to 18.1 mg/dL, ALT 7897 U/L, Alk P not given, INR 2.52, eosinophils 2,600/μL] with minimal response to high dose corticosteroids, was listed for liver transplant, but then had rapid improvement after a single dose of benralizumab [monoclonal anti-IL5]; reviews 9 cases in literature treated successfully with benralizumab). 40726873
Jáquez-Quintana JO, Ramos-Matamoros C, Gonzalez-Martinez CE, Herrera Elizondo JL. Lamotrigine induced drug reaction with eosinophilia and systemic symptoms (DRESS) presenting with eosinophilic pan-colitis, cholestasis and cytomegalovirus reactivation. Rev Esp Enferm Dig. 2025;117:683-684. (72 year old man with epilepsy recently switched from valproate to lamotrigine developed bloody diarrhea, fever, and jaundice and was found to have DRESS syndrome and cytomegalovirus pancolitis perhaps from reactivation due to immune dysregulation.). 39235190
Kelbrick M, Mustafa FA, Wilson H, Nyadzayo L, Ibrahim D, Paduret G. Lamotrigine-induced DRESS syndrome with myelosuppression in a patient with bipolar disorder: case report. Psychopharmacol Bull. 2026;56:126-130. (24 year old African woman with a mood disorder developed skin rash 9 days after starting lamotrigine which spread despite stopping the drug promptly and she developed fatigue, fever and weakness [ALT 766, Alk P and bilirubin not given] with neutropenia and normal or low eosinophils], resolving without specific therapy). 41531995
Afrin A, C K A, Anto MC, R N S. Double jeopardy: lamotrigine-induced drug reaction with eosinophilia and systemic symptoms (dress) complicated by valproate hepatotoxicity. Cureus. 2026;18:e101034. (17 year old boy with epilepsy on chronic therapy with valproate developed fever, generalized rash, lymphadenopathy, and hepatomegaly 6 weeks after adding lamotrigine [ALT initially 184, bilirubin and Alk P not given]; the rash improved after stopping lamotrigine and with corticosteroid therapy, but ALT levels continued to rise [to 2860 U/L] and fell only when the valproate dose was reduced and were normal 2 months later). 41658799
Bunch M, Klocke S, Woodrich N, Barritt AS 4th, Eyal S. Antiseizure treatments and liver injury: expect (and prevent) the unexpected. Epilepsy Curr. 2026 Jan 20:15357597251403348. Epub ahead of print. . (Review of antiseizure medication related liver injury emphasizing the hepatocellular and hypersensitivity phenotype of lamotrigine injury, the importance of slow dose escalation, the interaction with valproate, and need for prompt withdrawal when DILI or systemic hypersensitivity is suspected). 41574183
Holloway A, Weinberg I, Coakley G, Leandro M, Fisher C, Ciurtin C, Stern W, et al. Haemophagocytic lymphohistiocytosis precipitated by lamotrigine. Pract Neurol. 2026;26:146-149. . (Two adults developed HLH with refractory fever, cytopenias, high ferritin levels, and multiorgan failure within 10 days of starting lamotrigine; both recovered after lamotrigine withdrawal and treatment with intravenous corticosteroids, immunoglobulin, and anakinra). 40803834
Ali SB, King J, Lucas M. A narrative review of drug-induced haemophagocytic lymphohistiocytosis: a rare but relevant differential diagnosis. Int Arch Allergy Immunol. 2026:1-13. Epub ahead of print. (Review of the literature identified 39 cases of drug-induced HLH often presenting like DRESS [n=7] or SJS [n=3], but without eosinophilia and with immune dysregulation and high ferritin levels, most common due to lamotrigine [n=10] or beta-lactam antibiotics [n=12] with a high mortality rate [23%]). 41770659
Ünal D, Yeğit OO, Demir S, Erden B, Korkmaz P, Oğuz FS, Çınar ÇK, et al. Utility of patch testing, LTT, and HLA genotyping in identifying culprit drugs and diagnosing multiple drug hypersensitivity in definite DRESS: a 10-year cohort study. Clin Transl Allergy. 2026;16:e70172. (Among 50 patients with DRESS syndrome see at a single Turkish referral center between 2010 and 2024, 60% had hepatic involvement and HLA testing in 17 patients showed risk alleles of A*32:01 in 2 vancomycin, *31:01 in 2 carbamazepine, and A*24:02 in 1 lamotrigine case). 42014364

## OTHER REFERENCE LINKS

1. Recent References on Lamotrigine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(lamotrigine+AND+triazines/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Lamotrigine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=lamotrigine)